# Angiotensin II Receptor Antagonists

## OVERVIEW

The angiotensin II receptor antagonists, also known as angiotensin receptor blockers (ARBs), are a family of agents that bind to and inhibit the angiotensin II type 1 receptor (AT1) and thus inhibit the renin-angiotensin system and its cascade of effects in causing arteriolar contraction and sodium retention. While angiotensin converting enzyme (ACE) inhibitors block the cleavage of angiotensin I to angiotensin II, the active peptide that causes a pressor response, the ARBs inhibit its peripheral action. The ARBs reduce blood pressure in animal models as well as in humans. Since their introduction in 1995, these agents have been used widely in the therapy of hypertension and to reduce the complications of hypertensive cardiovascular disease and diabetic nephropathy.

The ARBs in clinical use in the United States include eight agents of similar chemical structure and activity, but somewhat different pharmacokinetics: losartan (Cozaar: 1995), valsartan (Diovan: 1996), irbesartan (Avapro: 1997), eprosartan (Teveten: 1997), candesartan (Atacand: 1998), telmisartan (Micardis: 1998), olmesartan (Benicar: 2002) and azilsartan (Edarbi: 2011). All of these agents have been associated with a minimal rate of serum enzyme elevations during chronic therapy (0.2% to 2%) which are usually mild-to-moderate in severity, self limited, and rarely require dose modification or discontinuation. As a class, the ARBs have been associated with rare instances of acute liver injury that is usually self limited in duration, but varies in clinical expression, being usually hepatocellular but occasional cholestatic in nature. The most common presentation of liver injury due to these agents is a cholestatic hepatitis arising within 1 to 8 weeks of starting and resolving as rapidly with stopping. Rare instances of prolonged jaundice have been described but not acute liver failure or autoimmune chronic hepatitis. Several Individual case reports of clinically apparent liver injury have been published in the literature for losartan, valsartan, irbesartan olmesartan and candesartan, but not specifically for azilsartan, eprosartan, and telmisartan, probably because these three have been in use for a shorter period of time and in fewer subjects.

Most ARBs and particularly olmesartan have been linked to rare instances of severe sprue-like enteropathy. The enteropathy typically presents with severe diarrhea and weight loss with variable degrees of fatigue, nausea and abdominal discomfort arising 6 months to many years after starting the ARB. Small intestinal histological findings resemble those of celiac disease with flattening of the duodenal villuous pattern and villous atrophy. However, anti-transglutaminase and endomysial antibodies (the serologic markers of celiac disease) are negative and there is little or no response to a gluten-free diet. Withdrawal of the ARB, however, results in prompt improvement in the diarrhea and gradual resolution of duodenal villous flattening. Some cases of this drug induced enteropathy have had accompanying serum aminotransferase elevations and fatty liver by imaging or liver biopsy, which, along with the diarrhea, resolve rapidly with stopping the medication.

The different angiotensin II receptor antagonists are discussed separately, but references on their hepatotoxicity are given together after this introductory section.

The following links are to individual drug records.

- Azilsartan
- Candesartan
- Eprosartan
- Irbesartan
- Losartan
- Olmesartan
- Telmisartan
- Valsartan

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Azilsartan | 147403-03-0 | C25-H20-N4-O5 | Azilsartan Chemical Structure
Candesartan | 139481-59-7 | C24-H20-N6-O3 | Chemical Structure for Candesartan
Eprosartan | 133040-01-4 | C23-H24-N2-O4-S | Chemical Structure for Eprosartan
Irbesartan | 138402-11-6 | C25-H28-N6-O | Chemical Structure for Irbesartan
Losartan | 124750-99-8 | C22-H23-Cl-N6-O.K | Chemical Structure for Losartan
Olmesartan | 144689-24-7 | C24-H26-N6-O3 | Chemical Structure for Olmesartan
Telmisartan | 144701-48-4 | C33-H30-N4-O2 | Chemical Structure for Telmisartan
Valsartan | 144701-48-4 | C24-H29-N5-O3 | Chemical Structure for Valsartan

## ANNOTATED BIBLIOGRAPHY

References updated: 13 January 2017

Zimmerman HJ. Cardiovascular agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 623-5. (Expert review of hepatotoxicity published in 1999; mentions a single case of hepatotoxicity from losartan with a positive rechallenge [Bosch 1997]).
De Marzio DH, Navarro VJ. Antihypertensives. Hepatotoxicity of cardiovascular and antidiabetic medications. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 522-6. (Review of hepatotoxicity of antihypertensive agents, mentions that cases of hepatotoxicity of candesartan, irbesartan, losartan and valsartan have been published, but none were fatal and were variable in both latency to onset [1 week to 6 months] and clinical presentation [cholestatic and hepatocellular]).
Michel T, Hoffman BB. Treatment of myocardial ischemia and hypertension. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 745-88. (Textbook of pharmacology and therapeutics).
Hillal-Dandan R. Nonpeptide angiotensin II receptor antagonists. Renin and angiotensin. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 736-9. (Textbook of pharmacology and therapeutics).
Goldberg AI, Dunlay MC, Sweet CS. Safety and tolerability of losartan potassium, an angiotensin II receptor antagonist, compared with hydrochlorothiazide, atenolol, felodipine ER, and angiotensin-converting enzyme inhibitors for the treatment of systemic hypertension. Am J Cardiol 1995; 75: 793-5. (Summary of adverse events during losartan therapy in prelicensure clinical trials in more than 2000 patients; most symptoms were no more frequent than with placebo; ALT elevations occurred in 1.9% of patients on losartan, but rates were similar in comparator arms). 18800461
Nygaard B, Strandgaard S. Marked hepatotoxicity associated with losartan treatment. Blood Press 1996; 5: 190-1. (Two women developed anicteric hepatitis on losartan: 55 year old developed back pain 3 weeks after starting losartan [bilirubin 1.3 mg/dL, ALT 650 U/L, Alk P 396 U/L], resolving within a month of stopping; 46 year old developed chest pain “a few months” after starting losartan [ALT 311 U/L, no bilirubin or Alk P given], resolving within 2 weeks of stopping). 8790930
MacKay JH, Arcuri KE, Goldberg AI, Snapinn SM, Sweet CS. Losartan and low-dose hydrochlorothiazide in patients with essential hypertension. A double-blind, placebo-controlled trial of concomitant administration compared with individual components. Arch Intern Med 1996; 156: 278-85. (In a controlled trial of losartan with or without hydrochlorothiazide [HCTZ] vs placebo in 703 patients with hypertension, there were no overall changes in serum aminotransferase levels or serious adverse events or dose modifications for any laboratory abnormality). 8572837
Bosch X. Losartan-induced hepatotoxicity. JAMA 1997; 278: 1572. (46 year old man developed jaundice one month after starting losartan [bilirubin 9.6 mg/dL, ALT 2574 U/L, Alk P 738 U/L], resolving within 4 months of stopping; 3 week rechallenge led to jaundice [Case 1 for losartan]; reply from Merck mentioning 80 reports of liver abnormalities among an estimated 2 million patients treated). 9370501
Sever P, Holzgreve H. Long-term efficacy and tolerability of candesartan cilexetil in patients with mild to moderate hypertension. J Human Hypertens 1997; 11 [Suppl 2]: S69-73. (Analysis of two phase III trials [489 and 298 patients] of candesartan in hypertension for 6 to 12 months found low rate of side effects [headache and back pain most frequent] and “No clinically relevant changes in laboratory parameters [apart from two cases of increased hepatic enzymes]”). 9331014
Andrade RJ, Lucena MI, Santalla F. Hepatic injury associated with losartan. Ann Pharmacother 1998; 32: 1371. (77 year old man developed fatigue 3 weeks after starting an excessive dose of losartan [150 mg daily] for hypertension [bilirubin 1.7 mg/dL, ALT 410 U/L, Alk P normal], resolving within 4 weeks of stopping). 9876824
McClellan KJ, Goa KL. Candesartan cilexetil. A review of its use in essential hypertension. Drugs 1998; 56: 847-69. (Review of pharmacology, clinical use and safety of candesartan: studies in 4147 patients given doses of 8 or 16 mg daily found low rate of adverse events, headache in 10%, cough in 1.6%, similar rates with placebo; ALT elevations occur in “occasional” patients, reported in 2 of 632 patients in one trial of candesartan given for 12 months). 9829158
McClellan KJ, Balfour JA. Eprosartan. Drugs 1998; 55: 713-8. (Review of pharmacology, clinical studies and safety of eprosartan; tolerability at doses of 400 to 1200 mg daily was similar to placebo: no mention of ALT elevations or hepatotoxicity). 9585867
McClellan KJ, Markham A. Telmisartan. Drugs 1998; 56: 1039-44. (Review of pharmacology, clinical studies and safety of telmisartan; tolerability at doses of 20 to 160 mg daily was similar to placebo: no mention of ALT elevations or hepatotoxicity). 9878991
Mazzolai L, Burnier M. Comparative safety and tolerability of angiotensin II receptor antagonists. Drug Saf 1999; 21: 23-33. (Review of safety and tolerability of different ARBs in clinical trials: “None of the compounds induced a clear, specific, dose dependent adverse effect that could be attributed to the drug": common complaints being headache, dizziness, and fatigue; ALT elevations occurred rarely and were transient and resolved despite continuation of therapy, only one case of ALT requiring discontinuation has been reported, with losartan and from the sponsor). 10433351
Sega R. Efficacy and safety of eprosartan in severe hypertension. Eprosartan Multinational Study Group. Blood Press 1999; 8: 114-21. (Among 118 patients with hypertension treated with eprosartan or enalapril for 2 weeks, side effects were mild and similar in both groups; ALT results not given). 10451039
Shusterman NH. Safety and efficacy of eprosartan, a new angiotensin II receptor blocker. Am Heart J 1999; 138 (3 Pt 2): 238-45. (Review of clinical efficacy and safety of eprosartan; no mention of hepatotoxicity or ALT elevations). 10467219
Burnier M, Brunner HR. Angiotensin II receptor antagonists. Lancet 2000; 355: 637-45. (Review of history, pharmacology, mechanism of action, clinical efficacy and safety of the angiotensin II receptor antagonists; “Occasional minor increases in liver enzymes were usually transient”). 10696996
Hariraj R, Stoner E, Jader S, Preston DM. Drug points: prolonged cholestasis associated with irbesartan. BMJ 2000; 321: 547. (62 year old developed jaundice 1 month after starting irbesartan with bilirubin 23.6 mg/dL, AST 177 U/L, Alk P 3193 U/L, slow recovery, 2 biopsies). 10968816
González-Jiménez D, Varela JM, Calderón E, Galindo J, González de la Puente MA. Candesartan and acute liver injury. Eur J Clin Pharmacol 2000; 56: 769-70. (70 year old developed abdominal pain and jaundice 2 weeks after starting candesartan with bilirubin 21 mg/dL, ALT 244 U/L, Alk P 221 U/L, resolution in 2 months). 11214790
Vallejo I, García Morillo S, Pamies E. [Acute hepatitis induced by candesartan]. Med Clin (Barc) 2000; 115: 719. Spanish. (41 year old developed jaundice 5 weeks after starting candesartan [bilirubin 20 mg/dL, ALT 2700 U/L, Alk P 321 U/L], resolved with stopping). 11141435
Markham A, Spencer CM, Jarvis B. Irbesartan: an updated review of its use in cardiovascular disorders. Drugs. 2000; 59: 1187-206. (Review of pharmacology, clinical use and side effects of irbesartan; analysis of pooled data from 9 studies in 2606 patients found low rate of adverse events; no mention of hepatotoxicity or ALT elevations). 10852648
Reñé JM, Buenestado J, Sesé E, Miñana JM. Acute hepatitis induced by valsartan. Med Clin (Barc) 2001; 117: 637-8. (54 year old woman developed jaundice 18 weeks after starting valsartan for hypertension [bilirubin 23.6 mg/dL, ALT 1664 U/L, Alk P 385 U/L], resolving within 2 months of stopping). 11714476
Chitturi S, Farrell GC. Drug-induced cholestasis. Semin Gastrointest Dis 2001; 12: 113-24. (Review of the causes of drug induced liver injury with cholestatic features). 11352118
Andrade RJ, Lucena MI, Fernández MC, Vega JL, García-Cortés M, Casado M, Guerrero-Sanchez E, et al. Cholestatic hepatitis related to use of irbesartan: a case report and a literature review of angiotensin II antagonist-associated hepatotoxicity. Eur J Gastroenterol Hepatol 2002; 14: 887-90. (56 year old man developed jaundice 8 days after starting irbesartan [bilirubin 7.5 to 16.1 mg/dL, ALT 2646 U/L, Alk P 305 U/L], with Alk P remaining elevated for 16 months, but biopsy not showing vanishing bile ducts). 12172412
Tabak F, Mert A, Ozaras R, Biyikli M, Ozturk R, Ozbay G, Senturk H, et al. Losartan-induced hepatic injury. J Clin Gastroenterol 2002; 34: 585-6. (52 year old woman developed jaundice 5 month after starting losartan [bilirubin not given, ALT 750 U/L], resolving after stopping but recurring within 2 weeks of restarting [bilirubin 8.9 mg/dL, ALT 941 U/L, Alk P 419 U/L], then resolving within 4 months of stopping). 11960076
Basile G, Villari D, Gangemi S, Ferrara T, Accetta MG, Nicita-Mauro V. Candesartan cilexetil-induced severe hepatotoxicity. J Clin Gastroenterol 2003; 36: 273-5. (61 year old woman developed fever, abdominal pain and jaundice 1 month after starting candesartan [bilirubin 27.2 rising to 46.8 mg/dL, ALT 918 U/L, Alk P 142 U/L], resolving in 8 weeks with prednisone therapy, biopsy showing bile duct loss and fibrosis: Case 1 of candesartan). 12590242
Kiykim A, Altintas E, Sezgin O, Sezer K, Tiftik N, Akbay E, Seyrek E, et al. Valsartan-induced hepatotoxicity in a HBsAg-Positive patient. Am J Gastroenterol 2003; 98: 507. (52 year old woman with hypertension and HBsAg without chronic ALT elevations developed jaundice 4 weeks after starting valsartan [peak bilirubin 7.8 mg/dL, ALT 780 U/L, Alk P 1840 U/L], resolving within 3 months of stopping). 12591083
Foruny Olcina JR, Moreira Vicente VF, Gómez García M, Morell Hita JL. [Irbesartan-induced acute hepatitis] Gastroenterol Hepatol 2004; 27: 71-2. Spanish. (59 year old developed jaundice 2 weeks after starting irbesartan [bilirubin 8.5 mg/dL, ALT 1378 U/L, Alk P 244 U/L], slow resolution over 4 months). 14733885
Péron JM, Robic MA, Bureau C, Vinel JP. [Irbesartan induced acute hepatitis: one case]. Gastroenterol Clin Biol 2005; 29: 747-8. French. (51 year old woman with fatty liver developed urticaria and myalgias 3 weeks after starting irbesartan [ALT 890 U/L, Alk P and bilirubin not given], resolving within 2-3 weeks of stopping). 16149188
Annicchiarico BE, Siciliano M. Could irbesartan trigger autoimmune cholestatic hepatitis? Eur J Gastroenterol Hepatol 2005; 17: 247-8. (69 year old man developed jaundice 1 month after starting irbesartan [bilirubin 31.9 mg/dL, ALT 1449 U/L, Alk P 515 U/L, ANA negative and normal IgG], responsing to corticosteroids, but relapsing on stopping, but then resolving without relapse after 2 years of corticosteroid therapy, still autoantibody negative). 15674105
White WB, Punzi HA, Murwin D, Koval SE, Davidai G, Neutel JM. Effects of the angiotensin II receptor blockers telmisartan vs valsartan in combination with hydrochlorothiazide 25 mg once daily for the treatment of hypertension. J Clin Hypertens(Greenwich) 2006; 8: 626-33. (Among 1109 patients with hypertension treated with either telmisartan or valsartan or placebo, therapy was well tolerated; no mention of ALT levels or liver injury). 16957424
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but no case was attributed to an angiotensin receptor blocker). 15390328
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, no cases were attributed to an angiotensin receptor blocker). 18955056
Schumacher H, Mancia G. The safety profile of telmisartan as monotherapy or combined with hydrochlorothiazide: a retrospective analysis of 50 studies. Blood Press Suppl 2008; 1: 32-40. (Among all patients enrolled in 50 clinical trials of telmisartan [~8000] alone or in combination with HCTZ, "hepatobiliary system disorders" developed in 0.1% of patients and changes in liver enzymes in <0.1%, but no details or definitions given). 18705533
Chrysant SG, Oparil S, Melino M, Karki S, Lee J, Heyrman R. Efficacy and safety of long-term treatment with the combination of amlodipine besylate and olmesartan medoxomil in patients with hypertension. J Clin Hypertens(Greenwich) 2009; 11: 475-82. (Among 1940 patients with hypertension treated for 8 weeks with varying combinations of olmesartan, amlodipine and placebo, safety and tolerability were comparable among groups: no mention of ALT elevations or liver injury). 19751459
Destro M, Preti P, D'Ospina A, Christian Achiri NN, Ricci AR, Cagnoni F. Olmesartan medoxomil: recent clinical and experimental acquisitions. Expert Opin Drug Metab Toxicol 2009; 5: 1149-57. (Review of olmesartan, 7th ARB approved for use in the United States, given as a medoxomil prodrug which is esterified during absorption; not metabolized by P450 system and rates of side effects are similar to those with placebo and include headache, dizziness and flu-like symptoms; no mention of ALT elevations or liver toxicity). 19689219
Punzi HA. Efficacy and safety of olmesartan medoxomil alone and in combination with hydrochlorothiazide. Expert Rev Cardiovasc Ther 2009; 7: 229-39. (Review of olmesartan, a specific inhibitor of the angiotensin II type 1 receptor [AT1] taken as a medoxomil prodrug, few drug-drug interactions, effective alone or in combinations, particularly with hydrochlorothiazide, well tolerated with only slightly increased frequency of side effects compared to placebo [dizziness]; no mention of ALT elevations or liver toxicity). 19296759
Drugs for hypertension. Treat Guidel Med Lett 2009; 7: 1-10. (Brief overview of drugs for hypertension with guidelines on their use with information on prices and toxicities, mentions that side effects of angiotensin II receptor antagonists are similar to those of ACE inhibitors but they do not cause cough and only rarely cause angioedema, loss of taste and hepatoxicity). 19107095
Jiménez-Sáenz M, Arroyo Q, Sanjuan M, Herrerías JM. [Candesartan-induced cholestatic hepatitis: a case report]. Gastroenterol Hepatol 2010; 33: 66-7. Spanish. (82 year old man developed jaundice 3 weeks after starting candesartan [bilirubin 6.8 rising to 22.2 mg/dL, ALT 272 U/L, Alk P 1045 U/L], resolving 8 weeks after stopping with prednisone therapy). 19713003
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, two of which were atttributed to antihypertensive agents [hydralazine and methyldopa], but none to angiotensive II receptor blockers). 20949552
Oertelt-Prigione S, Crosignani A, Gallieni M, Vassallo E, Podda M, Zuin M. Severe hepatic encephalopathy in a patient with liver cirrhosis after administration of angiotensin-converting enzyme inhibitor/angiotensin II receptor blocker combination therapy: a case report. J Med Case Reports 2010; 4: 141. (40 year old man with cirrhosis and nephrotic syndrome developed coma within a day of adding ramipril to losartan, therapy with marked elevation in ammonia levels, recovery within days of stopping and recurrence on restarting the combination). 20482828
Taglietti F, Del Nonno F, Baiocchini A, Falasca L, Pieri S, Capone A, Grilli E, et al. Acute hepatocellular and cholestatic injury during therapy with hydrochlorothiazide - clinicohistopathologic findings: a case report. J Med Case Rep 2010; 4: 332. (68 year old man developed fatigue and jaundice 10 days after starting hydrochlorothiazide and olmesartan [bilirubin 6.3 rising to 14.7 mg/dL, ALT 346 U/L, Alk P 1091 U/L], resolving within 3 months of stopping both drugs). 20964809
Baker WL, White WB. Azilsartan medoxomil: a new angiotensin II receptor antagonist for treatment of hypertension. Ann Pharmacother 2011; 45: 1506-15. (Systematic review of literature on safety and efficacy of azilsartan identified 3 full publications and 5 abstracts describing clinical trials; "Other laboratory findings, such as increases in serum creatinine or liver enzyme levels, occurred infrequently and at similar rates between all groups"; no mention of hepatotoxicity or clinically apparent liver injury). 22116996
Azilsartan medoxomil (Edarbi) the eighth ARB. Med Lett Drugs Ther 2011; 53(1364): 39-40. (Concise summary of the clinical efficacy, safety and costs of azilsartan shortly after its approval in the US; hepatotoxicity was not mentioned).21566544
Rubio-Tapia A, Herman ML, Ludvigsson JF, Kelly DG, Mangan TF, Wu TT, Murray JA. Severe spruelike enteropathy associated with olmesartan. Mayo Clin Proc 2012: 87: 732-8. (Clinical description of 22 patients with suspected olmesartan induced enteropathy, ages 47 to 81 years, presenting with chronic diarrhea, weight loss and fatigue arising 0.5-7 years after starting olmesartan, with villous flattening and atrophy on intestinal biopsy, lack of anti-endomyoseal and transglutaminase antibodies, not respondive to a gluten-free diet, but resolving promptly on stopping olmesartan and subsequent improvement in intestinal histology and ability to tolerate reintroduction of gluten). 22728033
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to antihypertensive agents or to angiotensin II receptor blockers). 23419359
Cyrany J, Vasatko T, Machac J, Nova M, Szanyi J, Kopacova M. Letter: telmisartan-associated enteropathy - is there any class effect? Aliment Pharmacol Ther 2014; 40: 569-70. . (71 year old woman developed diarrhea, weight loss, and duodenal villous atrophy, arising 2 months after starting telmisasrtan and resolving with stopping and without gluten withdrawal; no mention of liver test results). 25103353
Ianiro G, Bibbò S, Montalto M, Ricci R, Gasbarrini A, Cammarota G. Systematic review: Sprue-like enteropathy associated with olmesartan. Aliment Pharmacol Ther 2014; 40: 16-23. (Systematic review of 11 publications on olmesartan associated enteropathy in 54 patients, ages 47 to 87 years, half women, arising 6 months to 7 years after starting drug, marked by villous flattening and atrophy, absence of typical celiac-associated autoantibodies, non-response to gluten free diet, but prompt resolution with stopping olmesartan). 24805127
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to an angiotensin II receptor blocker). 24552865
Al-Halawani MZ, Thawabi M, Asslo F, Shaaban H, Shamoon F, Baddoura WJ. Losartan-induced ischemic hepatocellular hepatotoxicity: a case report and literature review. J Family Med Prim Care 2014; 3: 272-4. (65 year old woman developed abdominal pain and anusea 4 months after starting losartan for hypertension [bilirubin 2.7 mg/dL, ALT 1184 U/L, Alk P 142 U/L], with rapid improvement within 1-2 weeks of stopping). 25374869
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 were attributed to antihypertensive medications including one each to losartan, irbesartan and valsartan). 25754159
Negro A, Rossi GM, Santi R, Iori V, De Marco L. A case of severe sprue-like enteropathy associated with losartan. J Clin Gastroenterol 2015; 49: 794. (A 69 year old man developed chronic diarrhea, weight loss, anemia and low albumin, 3 years after starting losartan for hypertension with prompt resolution on stopping; no mention of liver test results). 26166143
Herman ML, Rubio-Tapia A, Wu TT, Murray JA. A case of severe sprue-like enteropathy associated with valsartan. ACG Case Rep J 2015; 2: 92-4. (71 year old woman with long history of refractory sprue unresponsive to gluten withdrawal had a prompt remission when valsartan was discontinued [duration of therapy not provided]; no mention of liver test abnormalities). 26157924
Non-Alcoholic Fatty Liver Disease Study Group, Dolci M, Nascimbeni F, Romagnoli D, Reggiani Bonetti L, Guaraldi G, Mascia MT, Lonardo A. Nonalcoholic steatohepatitis heralding olmesartan-induced sprue-like enteropathy. Dig Liver Dis 2016; 48: 1399-1401. (72 year old man developed fatigue and diarrhea 3 years after starting olmesartan [ALT 202, Alk P and bilirubin not given, liver biopsy showing steatosis, duodenal biopsy partial villous atrophy], with prompt resolution of ALT elevations and diarrhea within 3 weeks of stopping olmesartan). 27486047

## OTHER REFERENCE LINKS

1. Recent References on Angiotensin II Receptor Antagonists: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Angiotensinr+II+Receptor+Antagonists)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Angiotensin II Receptor Antagonists: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=(Angiotensinr+II+Receptor+Antagonists))